# Talazoparib

## OVERVIEW

### Introduction

Talazoparib is an orally available small molecule inhibitor of the DNA repair enzyme poly ADP-ribose polymerase (PARP) which is used as an antineoplastic agent in the treatment of selected cases of breast cancer. Talazoparib is associated with a moderate rate of serum aminotransferase elevations during therapy and is suspected to cause rare instances of clinically apparent acute liver injury.

### Background

Talazoparib (tal" a zoe' pa rib) is a potent small molecule inhibitor of polyadenosine 5’-diphosphoribose (ADP-ribose) polymerase (PARP), an enzyme involved in repair of single strand breaks in DNA and which is used in the therapy of breast cancer. In normal cells, DNA repair mechanisms include base excision repair for single strand DNA breaks, for which PARP plays an important role, and homologous recombination for double-strand DNA breaks for which the tumor suppressor proteins BRCA-1 and BRCA-2 are involved. In patients with cancers associated with BRCA mutations, and particularly those with breast and ovarian cancer, the cancer cells are particularly susceptible to PARP inhibitors which cause accumulation of DNA breaks and resultant cell necrosis. In several clinical trials, talazoparib has been found improve progression free survival in patients with advanced or metastatic HER-2 negative breast cancer with BRCA mutations. It is also being evaluated as therapy of other types of solid tumors that harbor germ-line BRCA mutations. Talazoparib was approved for therapy of breast cancer (HER negative, BRCA positive) in the United States in 2018 and is available in capsules of 0.25 and 1.0 mg under the brand name Talzenna. The recommended dose is 1 mg orally once daily, continued until progressive disease or intolerable toxicity occurs. Side effects are common and can include fatigue, nausea, vomiting, diarrhea, anorexia, headache, alopecia, anemia, neutropenia and thrombocytopenia. Uncommon, but potentially severe side effects include myelodysplastic syndromes, marked myelosuppression and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels are common during talazoparib therapy occurring in 33% of patients, but rising above 5 times the upper limit of the normal range in only 1%. The elevations are generally transient and not associated with symptoms or jaundice. Furthermore, similar rates of aminotransferase elevations were reported in control, comparator arms. Talazoparib has had limited clinical use but has not been linked to instances of acute liver injury with symptoms or jaundice. Because of the limited clinical experience with using talazoparib and other PARP inhibitors, their potential for causing liver injury is not well defined.

Likelihood score: E* (unproved but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The possible cause of the liver injury due to talazoparib is not known. Talazoparib has minimal hepatic metabolism and does not inhibit any of the major cytochrome P450 (CYP) metabolizing enzymes.

### Outcome and Management

Talazoparib therapy has been associated with transient serum aminotransferase elevations during therapy, but has not been linked to instances of acute liver injury with jaundice or symptoms. Serum aminotransferase elevations above 5 times the upper limit of normal (if confirmed) should lead to temporary discontinuation, which should be permanent if laboratory values do not improve significantly or resolve within a few weeks or if symptoms or jaundice arise.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Talazoparib – Talzenna®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Talazoparib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Talazoparib | 1207456-01-6 | C19-H14-F2-N6-O | Talazoparib chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 January 2019

Abbreviation: PARP, polyadenosine-5’-diphosphoribose polymerase.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of kinase inhibitors).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents published in 2013 before the availability of talazoparib and the small molecule PARP inhibitors).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy; mentions that serum ALT elevations were frequent during talazoparib therapy, but rates were lower than with standard therapy [34% vs 39%] and there were no cases of ALT elevations with symptoms or jaundice).
de Bono J, Ramanathan RK, Mina L, Chugh R, Glaspy J, Rafii S, Kaye S, S et al. Phase I, dose-escalation, two-part trial of the PARP inhibitor talazoparib in patients with advanced germline BRCA1/2 mutations and selected sporadic cancers. Cancer Discov 2017; 7: 620-9. (Among 110 patients with various BRCA positive solid tumors treated with different doses of talazoparib, the maximum tolerated dose was 1.0 mg/day and extended therapy was associated with complete responses, particularly in those with ovarian and breast cancer; no mention of ALT elevations or hepatotoxicity). 28242752
Turner NC, Telli ML, Rugo HS, Mailliez A, Ettl J, Grischke EM, Mina LA, et al. A phase II study of talazoparib after platinum or cytotoxic nonplatinum regimens in patients with advanced breast cancer and germline BRCA1/2 Mutations (ABRAZO). Clin Cancer Res 2018 Dec 18. [Epub ahead of print] (Among 83 women with advanced breast cancer and BRCA mutations treated with talazoparib, the overall objective response rate was 28% and while rates of ALT elevations were not provided, two subjects stopped treatment early because of liver test abnormalities). 30563931
Litton JK, Rugo HS, Ettl J, Hurvitz SA, Gonçalves A, Lee KH, Fehrenbacher L, et al. Talazoparib in patients with advanced breast cancer and a germline BRCA Mutation. N Engl J Med 2018; 379: 753-63. (Among 431 women with advanced breast cancer with BRCA mutations with talazoparib or single-agent standard therapy, median progression free survival was longer with talazoparib [8.6 vs 5.6 months], while serious adverse event rates were similar [32% vs 29%] and “hepatic toxicity” was less frequent [9% vs 20%]). 30110579
Gunjur A. Talazoparib for BRCA-mutated advanced breast cancer. Lancet Oncol 2018; 19: e511. (News report on results of trial of talazoparib for breast cancer [Litton 2018] stressing the need to compare talazoparib with standard first-line platinum-based chemotherapy and to better understand mechanisms of resistance to PARP inhibitors). 30146245
Hoy SM. Talazoparib: first global approval. Drugs 2018; 78: 1939-46. (Review of the mechanism of action, history of development, structure, pharmacology, efficacy and safety of talazoparib; mentions that “hepatic adverse events” were less frequent with talazoparib than standard therapy [9% vs 20%], but one patient died of suspected sinusoidal obstruction syndrome). 30506138

## OTHER REFERENCE LINKS

1. Recent References on Talazoparib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Talazoparib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Talazoparib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Talazoparib)